# Zanubrutinib

## OVERVIEW

### Introduction

Zanubrutinib is an oral inhibitor of Bruton’s tyrosine kinase that is used in the therapy of refractory mantle cell lymphoma. Zanubrutinib has been associated with a low rate of serum enzyme elevations during therapy, but has not been linked to cases of clinically apparent acute liver injury although it may pose a risk for reactivation of hepatitis B in susceptible patients.

### Background

Zanubrutinib (zan” ue broo’ ti nib) is an orally available, small molecule inhibitor of Bruton’s tyrosine kinase (BTK), which is an essential component in the B cell receptor signaling pathway. Inhibition of this pathway prevents B cell activation, differentiation and proliferation. Deficiency of BTK is the cause of X linked (Bruton’s) agammaglobulinemia, and B cell receptor signaling through BTK has been shown to be critical for proliferation and survival of malignant B lymphocytes in mantle cell lymphoma and CLL. Zanubrutinib was approved for use in the United States as therapy for refractory mantle cell lymphoma in 2019, the third small molecule Bruton’s tyrosine kinase inhibitor to become available in the United States. It is under evaluation as therapy of other B cell malignancies. Zanubrutinib is available in capsules of 80 mg under the brand name Brukinsa. The recommended dose is 320 mg daily in one or two divided doses. Side effects are common, but usually mild-to-moderate in severity; they include myelosuppression, fatigue, diarrhea, nausea, vomiting, anorexia, constipation, cough, musculoskeletal pain, rash and fever. Uncommon, but potentially serious side effects include severe bone marrow suppression, infections, bleeding, cardiac arrhythmias, hypertension, tumor lysis syndrome and embryo-fetal toxicity.

### Hepatotoxicity

In the prelicensure clinical trials of zanubrutinib in patients with mantle cell lymphoma, liver test abnormalities were frequent although usually mild. ALT elevations arose in 28% and bilirubin levels in 24% of subjects, but were above 5 times the upper limit of normal (ULN) in less than 1%. In these trials that enrolled over 600 patients, there were no reports of clinically apparent liver injury, early discontinuations because of liver injury or liver related deaths. Nonetheless, other Bruton’s kinase inhibitors (ibrutinib, acalabrutinib) have been associated with rare cases of acute liver injury including acute liver failure. With those agents, the latency to onset of liver injury varied from several weeks to 9 months. The injury was typically hepatocellular and immunologic features were uncommon. While the pattern of injury was hepatocellular, the course was atypical of an acute hepatitis-like injury and more similar to acute hepatic necrosis with early onset of hepatic failure. Other Bruton’s kinase inhibitors have also been linked to several instances of reactivation of hepatitis B that can be severe and has been linked to fatal outcomes.

Likelihood score: E* (unproven but suspected cause of clinically apparent liver injury including reactivation of hepatitis B in susceptible patients).

### Mechanism of Injury

The cause of possible liver injury from zanubrutinib is unknown, but features of the liver injury from other Bruton’s kinase inhibitors suggest some degree of direct hepatotoxicity. In contrast, reactivation of hepatitis B from Bruton’s kinase inhibition is likely due to the profound inhibition of B cell activity as occurs with rituximab (anti-CD20) which appears to lead to increased viral replication due to immune suppression, followed by immune recovery and acute liver injury. Zanubrutinib is metabolized in the liver via the cytochrome P450 system, largely CYP 3A4 and is susceptible to drug-drug interactions with agents that inhibit or induce this enzyme reactivity.

### Outcome and Management

Serum aminotransferase elevations above 5 times the upper limit of normal (if confirmed) should lead to dose reduction or temporary cessation. In patients with clinically apparent liver injury and jaundice, restarting therapy should be done with caution. Cross sensitivity to liver injury is uncommon among the tyrosine kinase inhibitors and, in many situations, switching to another tyrosine kinase inhibitor may be appropriate. Ibrutinib and acalabrutinib have been linked to cases of reactivation of hepatitis B which can be severe. Importantly, patients who are to receive long term therapy with zanubrutinib should be screened for hepatitis B (HBsAg and anti-HBc) and, if either or both are positive, given antiviral prophylaxis against reactivation (with an oral antiviral agent with potent activity against HBV such as entecavir or tenofovir) or monitored carefully for appearance or rises in HBV DNA levels with early initiative of antiviral therapy.

Drug Class: Antineoplastic Agents, Protein Kinase Inhibitors

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Zanubrutinib – Brukinsa®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/drugInfo.cfm?setid=3e08fe23-d70e-424c-bc51-1222e320f902)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Zanubrutinib | 1691249-45-2 | C27-H29-N5-O3

## ANNOTATED BIBLIOGRAPHY

References updated: 16 December 2019

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of tyrosine kinase receptor inhibitors).
DeLeve LD. Kinase inhibitors. Gefitinib. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, p. 556. (Review of hepatotoxicity of cancer chemotherapeutic agents, does not discuss the Bruton tyrosine kinase inhibitors).
Wellstein A, Giaccone G, Atkins MB, Sausville EA. Pathway targeted therapies: monoclonal antibodies, protein kinase inhibitors, and various small molecules. In, Brunton LL Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1203-36. (Textbook of pharmacology and therapeutics).
https://www.accessdata.fda.gov/drugsatfda_docs/nda/2019/213217Orig1s000MultidisciplineR.pdf (FDA website with product labels and initial medical review of the safety and efficacy of zanubrutinib; mentions on pages 116-117 that ALT elevations arose in 26% of patients but were above 5 times ULN in less than 1% and that no instance of severe hepatic injury was reported ).
Wang ML, Rule S, Martin P, Goy A, Auer R, Kahl BS, Jurczak W, et al. (2013). Targeting BTK with ibrutinib in relapsed or refractory mantle-cell lymphoma. N Engl J Med. (Among 111 patients with refractory mantle cell lymphoma treated with ibrutinib for 1-24 months, the objective response rate was 68% [complete in 21%]; listing of side effects does not include ALT elevations or hepatotoxicity).
Byrd JC, Furman RR, Coutre SE, Flinn IW, Burger JA, Blum KA, Grant B, et al. (2013). Targeting BTK with ibrutinib in relapsed chronic lymphocytic leukemia. N Engl J Med. (Among 85 patients with refractory CLL treated with ibrutinib as a single agent, the overall response rate was 71%; side effects included diarrhea [49%], fatigue [32%], cough [31%], arthralgias [27%], rash [27%], fever [27%], peripheral edema [21%] and hypertension [18%]; ALT elevations and hepatotoxicity were not listed or mentioned).
Ponader S, Burger JA. (2014). Bruton's tyrosine kinase: from X-linked agammaglobulinemia toward targeted therapy for B-cell malignancies. J Clin Oncol. (History of discovery of X-linked agammaglobulinemia, identification of BTK as its cause, elucidation of role of BTK in the pathway of B cell activation, and development of BTK inhibitors including ibrutinib).
(2014). Ibrutinib (Imbruvica) for chronic lymphocytic leukemia. Med Lett Drugs Ther. (Concise review of mechanism of action, efficacy, safety and cost of ibrutinib shortly after its approval for use in the US, mentions that serious adverse events include cytopenias, bleeding and infections; no mention of ALT elevations or hepatotoxicity).
de Jésus Ngoma P, Kabamba B, Dahlqvist G, Sempoux C, Lanthier N, Shindano T, Van Den Neste E, Horsmans Y. (2015). Occult HBV reactivation induced by ibrutinib treatment: a case report. Acta Gastroenterol Belg. (80 year old man with refractory CLL had anti-HBc in serum without HBsAg but with low levels of HBV DNA [85 IU/mL] and developed reactivation of hepatitis B 5 months after starting ibrutinib [HBV DNA 23 million IU/mL, HBsAg positive, ALT 103 U/L], responding to entecavir with decline in HBV DNA and ALT levels but remaining HBsAg positive).
Walter HS, Rule SA, Dyer MJ, Karlin L, Jones C, Cazin B, Quittet P, et al. (2016). A phase 1 clinical trial of the selective BTK inhibitor ONO/GS-4059 in relapsed and refractory mature B-cell malignancies. Blood. (Among 90 patients with B-cell malignancies treated with zanubrutinib in escalating doses, response rates were highest in those with CLL [96%] and mantel cell lymphoma [92%], and adverse events included anemia [32%], thrombocytopenia [18%], diarrhea [18%], rash [18%], fever [13%], neutropenia [12%], nausea [12%] and cough [11%]; no mention of ALT elevations or hepatotoxicity).
Nandikolla AG, Derman O, Nautsch D, Liu Q, Massoumi H, Venugopal S, Braunschweig I, Janakiram M. (2017). Ibrutinib-induced severe liver injury. Clin Case Rep. (62 year old man with refractory CLL and hematopoietic cell transplant was started on ibrutinib and developed progressive liver injury [bilirubin 7.0 rising to 35.2 mg/dL, ALT 743 U/L, Alk P 486 U/L], which persisted despite stopping ibrutinib until he died of progressive disease 4 months later).
Kahn A, Horsley-Silva JL, Lam-Himlin DM, Reeder CB, Douglas DD, Carey EJ. (2018). Ibrutinib-induced acute liver failure. Leuk Lymphoma. (59 year old woman with Waldenström's macroglobulinemia developed fatigue 9 months after starting ibrutinib [bilirubin 2.5 rising to 13.6 mg/dL, ALT 441 U/L, AST 2707 U/L, Alk P 159 U/L, INR 7.7, lactate 9.4 mmol/L], with slow resolution after stopping).
Wong J, Cher L, Griffiths J, Cohen A, Huang J, Wang L, Gregory G, et al. (2018). Efficacy of zanubrutinib in the treatment of Bing-Neel Syndrome. HemaSphere. (74 year old man with relapsed and refractory Waldenström macroglobulinemia and cervical and thoracic cord tumor infiltration had a clinical response to a 15 month course of zanubrutinib; no mention of adverse reactions or hepatotoxicity).
Guo Y, Liu Y, Hu N, Yu D, Zhou C, Shi G, Zhang B, et al. (2019). Discovery of zanubrutinib (BGB-3111), a novel, potent, and selective covalent inhibitor of Bruton's tyrosine kinase. J Med Chem. (Description of development and characterization of zanubrutinib, a second generation and more selective inhibitor of Bruton’s tyrosine kinase than ibrutinib having less activity against other kinase families such as EGFR and Src).
Tam CS, Trotman J, Opat S, Burger JA, Cull G, Gottlieb D, Harrup R, et al. (2019). Phase 1 study of the selective BTK inhibitor zanubrutinib in B-cell malignancies and safety and efficacy evaluation in CLL. Blood. (Among 89 patients with B cell malignancies treated with zanubrutinib [320 mg daily], the overall response rate was 96% and adverse events were common but generally mild-to-moderate; no mention of ALT elevations or hepatotoxicity and no liver related serious adverse events).

## OTHER REFERENCE LINKS

1 Recent References on Zanubrutinib: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Zanubrutinib%20AND%20Human%5bMH%5d%20AND%20(drug%20induced%20liver%20injury%20OR%20jaundice/CI%20OR%20bile%20duct%20diseases/CI%20OR%20liver/DE%20OR%20liver%20diseases/CI)%20AND%20(%221900%5C%5C1%5C%5C1%22%5bEDat%5d:%222999%5C%5C12%5C%5C31%22%5bEDat%5d))
2 Trials on Zanubrutinib: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Zanubrutinib)